# Anthrax Antitoxins

## OVERVIEW

### Introduction

High titers of antibody to infectious bacteria and viruses can be used to both prevent and treat infectious diseases. In particular, antitoxins have been shown to be beneficial in several forms of severe acute infections such as diphtheria, rabies and anthrax. The recent use of active anthrax spores as a bioweapon, particularly in acts of terror, has renewed research efforts to develop potent, rapidly active means of prevention and treatment of anthrax after purposeful or accidental exposure. Several monoclonal antibodies to anthrax antigens have been developed as part of research efforts in bioterrorism, of which two are commercially available: raxibacumab (2012) and obiltoxaximab (2016). These two agents were approved for use based upon the so called “Animal Rule”, which allows FDA approval based upon efficacy as shown in animal models of severe infectious diseases and upon safety data developed in healthy volunteers. Both monoclonal antibodies have had limited use in humans, but neither has been associated with serum enzyme elevations or with instances of clinically apparent liver injury during the limited preclinical safety evaluation in healthy volunteers. Updated information on prevention and treatment of anthrax is available from the Centers for Disease Control and Prevention on their website: https://www.cdc.gov/anthrax/index.html.

## OVERVIEW

### Introduction

Obiltoxaximab is a chimeric monoclonal antibody to the protective antigen of B. anthracis that is used to prevent and treat inhalation anthrax. Obiltoxaximab has had limited use in humans, but has not been associated with serum enzyme elevations during therapy or with instances of clinically apparent liver injury.

### Background

Obiltoxaximab (oh" bil tox ax i mab) is a human-mouse chimeric monoclonal antibody to the Bacillus anthrax protective antigen that is the major immunogenic antigen produced by the bacterial infection. The binding of obiltoxaximab to the anthrax protective antigen blocks the binding of the bacterial toxin to host cells. In several animal models of inhalation anthrax, obiltoxaximab ameliorated the course of the disease and, if given before the onset of signs and symptoms, prevented clinically apparent disease. Obiltoxaximab was approved for use in the United States in 2016 for the prevention and treatment of inhalation anthrax. The approval was based upon the efficacy of obiltoxaximab in animal models of anthrax and on data on safety and pharmacokinetics in healthy human volunteers. Human anthrax is exceedingly rare, but has occurred in the United States as a result of acts of terrorism. Obiltoxaximab is available in single use vials of 600 mg in 6 mL (100 mg/mL) under the brand name Anthim. The recommended dose is 16 mg/kg by slow (90 minute) intravenous infusion in adults and children above 40 kg in weight. Side effects were assessed in studies done in several hundred healthy adult volunteers. While described as “generally well tolerated” adverse events included headache, itching, rash, urticaria and local infusion and hypersensitivity reactions including anaphylaxis. Premedication with diphenhydramine (an antihistamine) is recommended.

### Hepatotoxicity

In human volunteer studies, obiltoxaximab was associated with local infusion and general hypersensitivity reactions, but clinical laboratory results were said to be unchanged over time. There have been no reports of hepatotoxicity associated with administration of obiltoxaximab.

Likelihood score: E (unlikely cause of liver injury, but it has had very limited use in humans).

### Mechanism of Injury

Obiltoxaximab is a monoclonal antibody and is unlikely to be inherently hepatotoxic. Recombinant proteins are often metabolized in the cells on which they act but are also metabolized in the liver, largely to small peptides and amino acids which may be reused to synthesize proteins and are unlikely to be toxic or immunogenic.

Drug Class: Antiinfective Agents, Antitoxins; Monoclonal Antibodies

## OVERVIEW

### Introduction

Raxibacumab is a human monoclonal antibody to the protective antigen of B. anthracis that is used to prevent and treat inhalation anthrax. Raxibacumab has had limited use in humans, but has not been associated with serum enzyme elevations during therapy or with instances of clinically apparent liver injury.

### Background

Raxibacumab (rax" ee bak' ue mab) is a human monoclonal IgG1 antibody to the Bacillus anthrax protective antigen, a major component of the lethal toxin of anthrax. The binding of raxibacumab to the anthrax protective antigen blocks the binding of the bacterial toxin to host cells. In several animal models of inhalation anthrax, raxibacumab ameliorated the course of the disease and, if given before the onset of signs and symptoms, prevented clinically apparent disease. Raxibacumab was approved for use in the United States in 2012 for the prevention and treatment (combined with appropriate antibiotics) of inhalation anthrax. The approval was based upon the efficacy of raxibacumab in animal models of anthrax and on data on safety and pharmacokinetics in healthy human volunteers. Human anthrax is exceeding rare, but has occurred in the United States as a result of acts of terrorism. Raxibacumab is available in single use vials of 1700 mg in 34 mL (50 mg/mL) under the brand name Raxibacumab. The recommended dose is 40 mg/kg by slow (135 minute) intravenous infusion in adults and children above 40 kg in weight. Side effects were assessed in studies done in several hundred healthy adult volunteers. While described as “generally well tolerated” and similar in rate to that in placebo recipients, adverse events included rash, pain, somnolence, and local infusion and hypersensitivity reactions. Premedication with diphenhydramine (an antihistamine) is recommended.

### Hepatotoxicity

In human volunteer studies, raxibacumab was associated with local infusion and general hypersensitivity reactions, but clinical laboratory results remained unchanged. There have been no reports of hepatotoxicity associated with administration of raxibacumab.

Likelihood score: E (unlikely cause of liver injury, but it has had very limited use in humans).

### Mechanism of Injury

Raxibacumab is a human monoclonal antibody and is unlikely to be inherently hepatotoxic. Recombinant proteins are often metabolized in the cells on which they act but are also metabolized in the liver, largely to small peptides and amino acids which may be reused to synthesize proteins and are unlikely to be toxic or immunogenic.

Drug Class: Antiinfective Agents, Antitoxins; Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Obiltoxaximab – Anthim®

Raxibacumab – Raxibacumab®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Obiltoxaximab%20) (Obiltoxaximab)

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=%20Raxibacumab) (Raxibacumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Obiltoxaximab | 1351337-07-9 | Monoclonal Antibody | Not Available
Raxibacumab | 565451-13-0 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 27 March 2017

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Migone TS, Subramanian GM, Zhong J, Healey LM, Corey A, Devalaraja M, Lo L, et al. (2009). Raxibacumab for the treatment of inhalational anthrax. N Engl J Med. (In both rabbits and monkeys exposed to lethal doses of B. anthracis spores, raxibacumab increased the survival rate, and antibody levels associated with protection in animals were readily achieved in humans given intravenous infusions of raxibacumab; adverse events included headache, upper respiratory tract infection, nausea, arm and leg pain, cough, and arthralgia, all of which were no more frequent with raxibacumab than with placebo).
(2013). Raxibacumab for anthrax. Med Lett Drugs Ther. (Concise review of the mechanism of action, efficacy in animal studies and safety in human volunteer studies of raxibacumab shortly after its approval for use in the United States; mentions mild-to-moderate adverse effects, but does not mention ALT elevations or hepatoxicity).
Hendricks KA, Wright ME, Shadomy SV, Bradley JS, Morrow MG, Pavia AT, Rubinstein E, et al., Workgroup on Anthrax Clinical Guidelines. (2014). Centers for disease control and prevention expert panel meetings on prevention and treatment of anthrax in adults. Emerg Infect Dis. (Summary of recommendations on the prevention and treatment of anthrax from a symposium held by the CDC).
Huang E, Pillai SK, Bower WA, Hendricks KA, Guarnizo JT, Hoyle JD, Gorman SE, et al. (2015). Antitoxin treatment of inhalation anthrax: a systematic review. Health Secur. (Systematic review of the literature on animal studies of the efficacy of antitoxin therapy for anthrax).
Tsai CW, Morris S. (2015). Approval of raxibacumab for the treatment of inhalation anthrax under the US Food and Drug Administration "Animal Rule". Front Microbiol. (Review of the animal and clinical data that supported the FDA approval of raxibacumab based upon the Animal Rule; no mention of ALT elevations or hepatotoxicity).
Huang B, Xie T, Rotstein D, Fang H, Frucht DM. (2015). Passive immunotherapy protects against enteric invasion and lethal sepsis in a murine model of gastrointestinal anthrax. Toxins (Basel). (In a mouse model, administration of raxibacumab at the same time as gastrointestinal exposure to anthrax spores prevented lethal sepsis in over 90% of cases).
Migone TS, Bolmer S, Zhong J, Corey A, Vasconcelos D, Buccellato M, Meister G. (2015). Added benefit of raxibacumab to antibiotic treatment of inhalational anthrax. Antimicrob Agents Chemother. (In rabbits exposed to lethal doses of anthrax spores, addition of raxibacumab to ciprofloxacin therapy improved the survival rate at 28 days [82% vs 65%]).
Nagy CF, Leach TS, Hoffman JH, Czech A, Carpenter SE, Guttendorf R. (2016). Pharmacokinetics and tolerability of obiltoxaximab: a report of 5 healthy volunteer studies. Clin Ther. (Among 340 healthy volunteers who received one or several doses of obiltoxaximab in phase 1 pharmacokinetic studies, adverse events included headache, itch, rash, urticaria and hypersensitivity reactions including anaphylaxis in 3 patients, while “clinical laboratory test results… were unremarkable and stable over time”).
Yamamoto BJ, Shadiack AM, Carpenter S, Sanford D, Henning LN, Gonzales N, O'Connor E, et al. (2016). Obiltoxaximab prevents disseminated Bacillus anthracis infection and improves survival during pre- and postexposure prophylaxis in animal models of inhalational anthrax. Antimicrob Agents Chemother. (In studies done in rabbits and macaques challenged with active anthrax spores, obiltoxaximab was highly effective in preventing overt disease and death when administered with antibiotics and prevented disease when administrated before onset).
Yamamoto BJ, Shadiack AM, Carpenter S, Sanford D, Henning LN, O'Connor E, Gonzales N, et al. (2016). Efficacy projection of obiltoxaximab for treatment of inhalational anthrax across a range of disease severity. Antimicrob Agents Chemother. (Prediction of the efficacy of obiltoxaximab in humans based upon antibody levels achieved in animal studies).
Greig SL. (2016). Obiltoxaximab: First global approval. Drugs. (Review of the clinical features of anthrax in humans and the challenges of developing therapy and FDA criteria under the Animal Rule whereby efficacy can be established by studies in animals alone; in human volunteer studies, obiltoxaximab was “generally well tolerated”, the major adverse events of concern being hypersensitivity reactions which arose in 5-10% of recipients of obiltoxaximab administered intravenously and occasionally qualified as being anaphylaxis).

## OTHER REFERENCE LINKS

1 Recent References on Obiltoxaximab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Obiltoxaximab/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2 Recent References on Raxibacumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Raxibacumab/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
3 Trials on Obiltoxaximab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Obiltoxaximab)
4 Trials on Raxibacumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Raxibacumab)